# Vigabatrin

## OVERVIEW

### Introduction

Vigabatrin is a GABA derivative that is used in combination with other agents as therapy of refractory complex partial seizures and as monotherapy for infantile spasms. Vigabatrin is associated with a paradoxical decrease in serum enzyme levels during therapy, explained by its direct inhibition of aminotransferase activity. Vigabatrin has not been convincingly linked to cases of clinically apparent liver injury, but was linked to a fatal case of Reye syndrome in a child with severe developmental delay.

### Background

Vigabatrin (vye ga' ba trin) is a vinyl derivative of gamma-aminobutyric acid (GABA) that acts as a competitive inhibitor of GABA transaminase. Vigabatrin prevents the breakdown of GABA and thus may increase GABAergic, neuroinhibitory activity. Vigabatrin has been shown to be effective in reducing seizure activity as add on therapy in patients with refractory partial onset seizures. It was available in other countries for more than a decade before it was approved for use in the United States in 2009. Current indications include as adjuvant therapy in patients with refractory complex partial seizures and as monotherapy for infantile spasms in children ages 1 month to 2 years. Vigabatrin is available in tablets of 500 mg and as a powder for oral solution generically and under the brand name Sabril. The typical initial dose is 500 mg twice daily, with subsequent increases to a recommended average dose of 3000 mg daily in adults and 2000 mg in children 10 to 16 years of age. Doses for children with infantile spasms are weight based. Side effects may include fatigue, somnolence, nystagmus, tremor, blurred vision, memory impairment, mood changes, confusion and weight gain. Rare, but severe adverse events include visual loss, visual field constriction and retinal dysfunction, for which reason vigabatrin is available only through a restricted program that requires prospective ophthalmologic monitoring.

### Hepatotoxicity

In controlled clinical trials, addition of vigabatrin to standard anticonvulsant therapy was reported to cause an immediate and marked decrease in serum enzyme levels that could be reproduced by simply mixing vigabatrin with plasma. In some instances, markedly raised serum ALT levels were found to rapidly fall into the normal range with treatment. Vigabatrin inhibits GABA transaminase and is thus suspected of also being an inhibitor of alanine and aspartate aminotransferase, accounting for its unusual effects on liver associated enzymes. In prelicensure clinical trials, there were no reports of serum enzyme elevations during treatment and no instances of clinically apparent liver injury. After its general availability, however, there have been isolated case reports of severe liver injury and hepatitis associated with vigabatrin use. The onset of injury was 3 to 10 months after starting vigabatrin and was largely hepatocellular. One case resulted in rapid death from liver failure and a second worsened despite stopping and ultimately required a course of immunosuppression with prednisone and azathioprine (Case 1). Thus, clinically apparent liver injury from vigabatrin may occur and can be severe, but is rare.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Vigabatrin is an amino acid derivative and is metabolized by many tissues in the body. It is unlikely to be directly hepatotoxic and is not reported to cause drug-drug interactions. Instances of liver injury from vigabatrin are likely to be due to hypersensitivity.

### Outcome and Management

Patients who have developed serious hypersensitivity reactions to aromatic anticonvulsants such as phenytoin, carbamazepine and lamotrigine have later tolerated therapy with vigabatrin without recurrence. The structure of vigabatrin would suggest that it does not share sensitivity to other anticonvulsant agents.

Drug Class: Anticonvulsants

## CASE REPORT

### Case 1. Acute hepatitis attributed to vigabatrin.(1)

A 25 year old woman was found to have abnormal liver tests 10 months after starting vigabatrin for partial onset seizures. The serum bilirubin was minimally raised (2.0 mg/dL), but ALT values were 10 times and AST 8 times the upper limit of normal (Table). Vigabatrin was continued, but several weeks later she developed symptoms of fatigue and nausea and repeat blood testing showed persistence of the liver test abnormalities. Vigabatrin was stopped and she was referred for further evaluation. She denied a history of liver disease, alcohol abuse or risk factors for viral hepatitis. She was not taking other medications and denied use of over-the-counter drugs or herbal supplements. Physical examination was unremarkable and showed no fever or rash. Tests for acute hepatitis A, B and C were negative as were tests for EBV and CMV infection. Autoantibodies were not detected. Imaging of the liver by ultrasound was normal. A liver biopsy showed panlobular hepatitis with hepatocellular necrosis and inflammatory infiltrates of lymphocytes and eosinophils. Plasma cells and neutrophils were not prominent and there was no fat or fibrosis. Despite stopping vigabatrin, she continued to worsen and serum bilirubin rose to 4.1 mg/dL and prothrombin index fell to 54%. Because of the worsening and the possibility of autoimmune liver injury, prednisone and azathioprine were started, but blood tests had already showed evidence of improvement. Thereafter, she improved rapidly, and she was asymptomatic and all tests were normal one month later. The immunosuppressive therapy was gradually tapered and was stopped after 4 months. In follow up 8 months later, all liver tests remained normal.

#### Key Points

Medication: | Vigabatrin
Pattern: | Hepatocellular (R ratio=6.6)
Severity: | Moderate (jaundice and hospitalization)
Latency: | 10 months
Recovery: | 2 months (with prednisone and azathioprine therapy)
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
7 months | 0 | 35 | | 0.6 | On therapy
10 months | 0 | 400 | | 2.0
10.5 months | 0 | 440 | 125 | 2.4 | Vigabatrin stopped
| 1 week | 1680 | | 4.1
11 months | 2 weeks | 1200 | | 3.0 | Prednisone started
| 3 weeks | 640 | | 2.2
| 1 month | 45 | | 1.3
1 year | 2 months | 35 | | 0.7
| 4 months | 30 | | 0.6 | Prednisone stopped
2 years | 1 year | 30 | | 0.5 | Asymptomatic
Normal Values | | <40 | <125 | <1.2

* Estimated from Figure 1 and converted to U/L based upon default normal values.

#### Comment

A woman with partial onset seizures developed evidence of acute hepatitis 10 months after starting vigabatrin. She was taking no other medications and had no risk factors for viral hepatitis. Medical evaluation revealed no evidence for other forms of liver disease, and a liver biopsy was compatible with drug induced liver injury. Because of concerns over the severity of the injury and the possibility of an early autoimmune hepatitis, prednisone and azathioprine were started, but blood tests showed evidence of improvement even before these medications was started. In follow up, she was able to stop the immunosuppressive regimen without recurrence of injury, strong evidence against autoimmune hepatitis. This was a fairly convincing case of vigabatrin induced liver injury. The absence of other reports may merely reflect the fact that the drug is rarely used, particularly as monotherapy. Vigabatrin is approved in the United States, only as adjunctive therapy to be used with other anticonvulsant agents for partial seizures in adults. Its serious adverse events (particularly retinal) have limited it more wide scale use. Why a simple GABA derivative would cause liver toxicity is unclear. Despite the absence of signs of hypersensitivity, the most likely explanation is immunologic.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vigabatrin – Generic, Sabril®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vigabatrin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Vigabatrin | 68506-86-5 | C6-H11-N-O2
GABA (Gamma-Aminobutyric Acid) | 56-12-2 | C4-H9-N-O2

## CITED REFERENCE

1 Locher C, Zafrani ES, Dhumeaux D, Mallat A. (2001). Gastroenterol Clin Biol.

## ANNOTATED BIBLIOGRAPHY

References updated: 31 July 2020

Abbreviations used: SJS/TEN, Stevens-Johnson syndrome and toxic epidermal necrolysis.

Kaplowitz Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999 before the availability of vigabatrin).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; vigabatrin is not discussed).
Smith MD, Metcalf CS, Wilcox KS. Pharmacology of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Remy C, Beaumont D. (1989). Efficacy and safety of vigabatrin in the long-term treatment of refractory epilepsy. Br J Clin Pharmacol. (Among 254 patients with refractory seizures treated with vigabatrin for an average of 23 months, “there was some alterations in liver transaminases” including a 30-50% decrease in ALT).
Ben-Menachem E, Persson L, Mumford J. (1990). Long-term evaluation of once daily vigabatrin in drug-resistant partial epilepsy. Epilepsy Res. (Among 35 patients with refractory partial onset seizures treated with adjunctive vigabatrin for up to 3 years, there were no changes in routine chemistry laboratory tests “that were considered to be clinically significant”).
Browne TR, Mattson RH, Penry JK, Smith DB, Treiman DM, Wilder BJ, Ben-Menachem E, et al. (1991). Multicenter long-term safety and efficacy study of vigabatrin for refractory complex partial seizures: an update. Neurology. (Among 66 patients with refractory seizures who received vigabatrin as add on therapy for 5-72 months, there were no abnormalities in laboratory studies).
Tartara A, Manni R, Galimberti CA, Morini R, Mumford JP, Iudice A, Perucca E. (1992). Six-year follow-up study on the efficacy and safety of vigabatrin in patients with epilepsy. Acta Neurol Scand. (Among 25 patients with partial onset seizures with a favorable response to adjunctive vigabatrin therapy and who were continued on treatment for 2-6 years, “there were no significant changes in standard…blood chemistry…tests” and no serious adverse events or need for discontinuation due to liver injury).
Cocito L, Maffini M, Loeb C. (1993). Vigabatrin in chronic epilepsy: a 7-year follow-up study of responder patients. Seizure. (Among 35 adults with epilepsy treated with vigabatrin as add on therapy for refractory epilepsy, 23 were continued on drug in an extension study, among whom there were “no significant effects” on any of the routine laboratory tests).
Williams A, Goldsmith R, Coakley J. (1994). Profound suppression of plasma alanine aminotransferase activity in children taking vigabatrin. Aust N Z J Med. (Among 12 children [ages 2 to 17 years] with poorly controlled seizures who were treated with vigabatrin, serum ALT levels decrease in all 12, from 13-72 U/L to 0-26 U/L, perhaps due to inhibition of alanine and aspartate as well as GABA transaminase).
Kellermann K, Soditt V, Rambeck B, Klinge O. (1996). Fatal hepatotoxicity in a child treated with vigabatrin. Acta Neurol Scand. (3 year old boy with developmental delay and seizures treated with phenobarbital developed fever and coma 3 months after the addition of vigabatrin [bilirubin not given, AST 54 rising to 577 U/L, ammonia 214 μmol/L] and progressive coagulopathy leading to death in 3 days, autopsy showing massive necrosis without fat, although mitochondrial changes suggested Reye syndrome).
Williams A, Sekaninova S, Coakley J. (1998). Suppression of elevated alanine aminotransferase activity in liver disease by vigabatrin. J Paediatr Child Health. (In a 16 month old boy with Alpers syndrome, severe developmental delay and liver disease, addition of vigabatrin to standard anticonvulsant therapy was followed by day 15 by a 91% decrease in ALT [247 to 18 U/L] and 19% decrease in Alk P levels [into the normal range], effects that could be reproduced in vitro, by addition of vigabatrin to plasma).
Bruni J, Guberman A, Vachon L, Desforges C. (2000). Vigabatrin as add-on therapy for adult complex partial seizures: a double-blind, placebo-controlled multicentre study. The Canadian Vigabatrin Study Group. Seizure. (Among 111 patients with refractory partial onset seizures who were treated with vigabatrin or placebo for 36 weeks, there were “no clinically significant abnormalities” of laboratory test results).
Guberman A, Bruni J. (2000). Long-term open multicentre, add-on trial of vigabatrin in adult resistant partial epilepsy. The Canadian Vigabatrin Study Group. Seizure. (Among 97 patients with refractory partial onset seizures who had completed participation in a placebo controlled trial and were continued on vigabatrin for up to 1 year, there were marked reductions in serum ALT, and no patient had a liver related serious adverse event or had to discontinue therapy because of liver injury).
Locher C, Zafrani ES, Dhumeaux D, Mallat A. (2001). Gastroenterol Clin Biol. (25 year old woman with partial onset seizures developed acute hepatitis 10 months after starting vigabatrin [bilirubin 2.0 rising to 4.1 mg/dL, ALT 10 rising to 45 times ULN, Alk P 1.5 times ULN), ultimately treated with prednisone and azathioprine and improving rapidly, but able to stop all immunosuppression several months later without relapse: Case 1).
Galindo PA, Borja J, Gómez E, Mur P, Gudín M, García R, Encinas C, et al. (2002). Anticonvulsant drug hypersensitivity. J Investig Allergol Clin Immunol. (Among 15 patients with cutaneous hypersensitivity reactions to anticonvulsants [9 accompanied by liver test elevations] which were caused by carbamazepine [n=8], phenytoin [5], lamotrigine [4], phenobarbital [4], valproate [1] and felbamate [1], two patients later tolerated vigabatrin without recurrence).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of the hepatotoxicity of anticonvulsants; no discussion of vigabatrin).
Camposano SE, Major P, Halpern E, Thiele EA. (2008). Vigabatrin in the treatment of childhood epilepsy: a retrospective chart review of efficacy and safety profile. Epilepsia. (Among 84 children treated with vigabatrin for infantile spasms or partial onset seizures or both, side effects were uncommon and usually mild, leading to discontinuation in only 3 children, all 3 for psychiatric symptoms).
(2010). Vigabatrin (Sabril) for epilepsy. Med Lett Drugs Ther. (Concise summary of mechanism of action, clinical efficacy, adverse events and costs of vigabatrin shortly after its approval for use in the US mentions the serious adverse events of retinal dysfunction, intramyelinic edema and suicidal ideation as well as the common adverse events of anticonvulsants such as headache, fatigue, pain, ataxia, dizziness, somnolence, weight gain, depression and alterations in behavior, mood and thinking; no mention of ALT elevations or hepatotoxicity).
Walker SD, Kälviäinen R. (2011). Non-vision adverse events with vigabatrin therapy. Acta Neurol Scand Suppl. (Review of the common adverse events of vigabatrin therapy does not mention ALT elevations or hepatotoxicity).
Gaitatzis A, Sander JW. (2013). The long-term safety of antiepileptic drugs. CNS Drugs. (Review of the long term safety and adverse event profile of anticonvulsants mentions that valproate and felbamate can cause liver failure, but does not mention hepatotoxicity of other anticonvulsants).
(2013). Drugs for epilepsy. Treat Guidel Med Lett. (Concise review of indications and side effects of anticonvulsants; vigabatrin is approved as add on therapy of Lennox-Gastaut syndrome in children and adults; discussion of adverse effects does not mention hepatotoxicity, but mentions that vigabatrin is a mild inducer of CYP 3A4).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but of the 96, none were attributed to vigabatrin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsants, but none to vigabatrin).
Vidaurre J, Gedela S, Yarosz S. (2017). Antiepileptic drugs and liver disease. Pediatr Neurol. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin, levetiracetam, being an "ideal" first line therapy for patients with liver disease because of its safety and lack of pharmacokinetic interactions).
(2017). Drugs for epilepsy. Med Lett Drugs Ther. (Concise review of the drugs available for therapy of epilepsy lists vigabatrin as being available only through a restricted distribution program because of concerns about retinal toxicity; no mention of hepatotoxicity or changes in ALT levels).
Borrelli EP, Lee EY, Descoteaux AM, Kogut SJ, Caffrey AR. (2018). Stevens-Johnson syndrome and toxic epidermal necrolysis with antiepileptic drugs: An analysis of the US Food and Drug Administration Adverse Event Reporting System. Epilepsia. (Review of adverse event reports to the FDA between 2014 and 2018 identified ~2.9 million reports, 1034 for SJS/TEN, the most common class of drugs being anticonvulsants with 17 of 34 having at least one report, those most frequently linked being lamotrigine [n=106], carbamazepine [22], levetiracetam [14], phenytoin [14], valproate [9], clonazepam [8] and zonisamide [7]; no mention of vigabatrin).
Somoza EC, Winship D, Gorodetzky CW, Lewis D, Ciraulo DA, Galloway GP, Segal SD, et al. (2013). A multisite, double-blind, placebo-controlled clinical trial to evaluate the safety and efficacy of vigabatrin for treating cocaine dependence. JAMA Psychiatry. (Among 186 adults with cocaine dependency treated with vigabatrin or placebo for 13 weeks, abstinence rates were similar [7.6% vs 5.3%] as were adverse event rates, although one vigabatrin treated subject developed acute hepatitis [specific data not provided]).
Jackson MC, Jafarpour S, Klehm J, Thome-Souza S, Coughlin F, Kapur K, Loddenkemper T. (2017). Effect of vigabatrin on seizure control and safety profile in different subgroups of children with epilepsy. Epilepsia. (Among 103 children treated with vigabatrin with electronic medical record follow up data, seizure frequency decreased by at least half in 73% of children while 20% of children had adverse events, the most common being visual changes [8.5%]; no mention of ALT abnormalities or hepatotoxicity).
Ohtsuka Y. (2018). Efficacy and safety of vigabatrin in Japanese patients with infantile spasms: Primary short-term study and extension study. Epilepsy Behav. (Among 13 Japanese children with infantile spasms treated with vigabatrin, 8 [62%] had a 50% or greater decrease in seizure frequency and none had a serious adverse event or peripheral visual defect reported).
Hussain SA. (2018). Treatment of infantile spasms. Epilepsia Open. (Review of the clinical features, natural history and therapy of infantile spasms, the most common form of epilepsy presenting in the first year of life, vigabatrin being a first line therapy which is limited by concerns of retinopathy and MRI evidence of central nervous system toxicity associated with long term use; no mention of hepatotoxicity or ALT elevations).
Cano-Paniagua A, Amariles P, Angulo N, Restrepo-Garay M. (2019). Epidemiology of drug-induced liver injury in a University Hospital from Colombia: Updated RUCAM being used for prospective causality assessment. Ann Hepatol. (Among 286 patients with liver test abnormalities seen in a single hospital in Colombia over a 1 year period, 17 were diagnosed with drug induced liver injury, the most common cause being antituberculosis therapy [n=6] followed by anticonvulsants [n=3, 1 each due to phenytoin, gabapentin and valproate]).

## OTHER REFERENCE LINKS

1 Recent References on Vigabatrin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vigabatrin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Vigabatrin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vigabatrin)